# Stavudine

## OVERVIEW

### Introduction

Stavudine is a first generation nucleoside analogue and reverse transcriptase inhibitor used in combination with other agents in the therapy of human immunodeficiency virus (HIV) infection and the acquired immunodeficiency syndrome (AIDS). Stavudine is an uncommon, but well established cause of clinically apparent acute and chronic liver injury.

### Background

Stavudine (stav' ue deen) is a synthetic thymidine analogue (2’,3’-didehydro-2’3’- dideoxydeoxythymidine: d4T) that inhibits HIV replication by competing with naturally occurring thymidine for incorporation into the growing viral DNA chain, causing inhibition of the viral polymerase (reverse transcriptase) and chain termination. Stavudine was approved for use in the treatment of HIV infection in the United States in 1994 and was widely used in many antiretroviral regimens for many years. Recently, stavudine has been replaced by other better tolerated second generation nucleoside analogues and is no longer commonly used in developed countries. It is, however, still used in resource limited settings. Stavudine is available in multiple generic forms and formerly under the brand name Zerit in 15, 20, 30, and 40 mg capsules. Oral solutions of stavudine (1 mg/mL) are also available. The recommended dose of stavudine is 30 to 40 mg orally every 12 hours in adults and in children greater than 30 kg. Common side effects include diarrhea, headache, macrocytosis, nausea and vomiting, peripheral neuropathy and rash. Less common but potentially severe adverse reactions include hepatotoxicity, peripheral neuropathy, lipoatrophy, pancreatitis and immune reconstitution syndrome.

### Hepatotoxicity

Stavudine is a well known cause of liver injury and is regularly listed in case series of drug induced liver injury and acute liver failure. Mild and transient elevations in liver enzymes occur in up to half of patients on stavudine, but elevations above 5 times normal occur in only 5% to 13% of treated patients. Clinically apparent hepatotoxicity due to stavudine is well described and is usually marked by lactic acidosis, marked hepatic steatosis (microvesicular fat), and progressive hepatic synthetic dysfunction (LASH). This form of liver injury typically arises only after 2 to 6 months of therapy and is preceded by nonspecific prodromal symptoms of anorexia, nausea, vomiting, diarrhea, and weakness which is followed by dyspnea, jaundice and confusion. Lactic acidosis often accompanies the hepatic injury and may be the predominant clinical feature. Jaundice arises late and serum enzymes are unusually only mildly or moderated elevated, the pattern being mixed or actually cholestatic. Pancreatitis, myopathy and neuropathy may also occur. Lipodystrophy is frequently present. Liver histology during the early course of injury demonstrates marked microvesicular fat with little hepatocyte injury. Subsequently, cholestasis arises and the fatty change may evolve to a macrovesicular pattern. Late changes include ballooning cell degeneration, Mallory bodies and fibrosis. The hepatotoxicity associated with stavudine can be rapidly fatal, but is potentially reversable with intensive support and early withdrawal of therapy (Case 1). Monitoring of patients on stavudine demonstrates that asymptomatic elevations of serum lactate (hyperlactatemia) usually precedes the appearance of clinical symptoms and acidosis. Once lactic acidosis is present, however, the mortality rate is high (33% to 50%) (Case 2). Preexisting liver injury, female sex, older age, obesity, alcohol use and concurrent therapy with didanosine, ribavirin and tenofovir appear to increase the risk of this syndrome in patients taking stavudine.

Stavudine and other first generation nucleoside analogues used to treat HIV infection have also been linked to cases of chronic liver injury, marked by appearance of signs and symptoms of portal hypertension and liver nodularity without significant fibrosis or cirrhosis after long term use. Nodular regenerative hyperplasia or “noncirrhotic portal hypertension” arise after long term therapy with antiretroviral therapies most typically with didanosine. In some cases, the first complications of portal hypertension arise months or years after the implicated agent is stopped and while other, less hepatotoxic agents are being used. Nodular regenerative hyperplasia is typically characterized by the appearance of signs and symptoms of portal hypertension and advanced liver disease, such as ascites or variceal hemorrhage, with no obvious cause (absence of hepatitis B or C and no history of alcohol abuse or nonalcoholic steatohepatitis). Serum enzymes are only modestly elevated and bilirubin levels can be normal. Liver biopsy can look deceptively benign, with little or no fibrosis and nodularity that is only obvious with reticulum stains that highlight the altered architecture. These patients have typically been receiving multiple antiretroviral agents and the attribution to stavudine alone cannot always be made. Didanosine is most frequently implicated in causing nodular regenerative hyperplasia but isolated instances have also been linked to stavudine, zidovudine and in rare instances tenofovir. The signs and symptoms of portal hypertension tend to improve once the nucleoside analogues are stopped and medical therapy of ascites and portal hypertension is begun.

Likelihood score: A (uncommon well established cause of acute and chronic forms of liver disease).

### Mechanism of Injury

Acute, clinically apparent hepatotoxicity from stavudine is typically associated with lactic acidosis and is probably mediated by widespread depletion or dysfunction of mitochondria. In vitro, stavudine has been found to inhibit the gamma polymerase responsible for replication of mitochondria and maintenance of mitochondrial function and numbers. The mitochondrial failure in hepatocytes leads to inability to metabolize lactic acid and free fatty acids and to support usual hepatic synthetic and excretory function. Mitochondrial injury to other tissue can lead to pancreatitis, myopathy and neuropathy. The chronic liver injury from stavudine is probably due to vascular damage to small arterioles and venules that causes a regenerative hyperplasia. The mechanism of the injury is not known, but may also be due to chronic mitochondrial injury.

### Outcome and Management

The severity of the liver injury associated with stavudine ranges from mild and transient enzyme elevations to rapidly progressive liver failure with steatosis leading to death. Stavudine is usually listed as one of the most frequent causes of drug induced acute liver failure. Most patients, however, recover from injury particularly if lactic acidosis is not advanced when therapy is stopped. Typically, improvement starts within 2 weeks of stopping stavudine, but may be slow to completely resolve. Rechallenge may lead to recurrence and should be avoided. Persons who develop stavudine hepatotoxicity should avoid use of other dideoxynucleosides such as didanosine and zalcitabine, and caution should be used in use of zidovudine (although it is usually well tolerated without recurrence of lactic acidosis). Various interventions have been used in attempts to treat the severe lactic acidosis and hepatic steatosis induced by nucleoside analogues. These interventions have included bicarbonate infusions, thiamine, riboflavin, l-carnitidine, as well as renal dialysis and mechanical ventilation. Intravenous 20% glucose decreases lactic acid levels in some patients, probably by providing intracellular ATP from anaerobic glycolysis. Liver transplantation has reversed lactic acidosis in the rare patient that has undergone emergency transplantation, but this option is rarely feasible. Stavudine has not been associated with chronic cholestasis or the vanishing bile duct syndrome.

Nodular regenerative hyperplasia from long term therapy with stavudine, didanosine or zidovudine should be treated conservatively with management of the signs and symptoms of portal hypertension. Stavudine (and all first generation nucleoside analogues) should be discontinued and the patient switched to other antiretroviral agents. Typically, nodular regenerative hyperplasia improves after drug withdrawal, and symptoms, signs and abnormal liver tests may ultimately resolve. The long term consequences of nodular regenerative hyperplasia after drug withdrawal is uncertain and not well defined. Unrelated acute severe medical conditions such as pneumonia or sepsis can cause reappearance of signs and symptoms of portal hypertension (ascites, variceal hemorrhage) and evidence of hepatic decompensation (weakness, jaundice, and hepatic encephalopathy).

Drug Class: Antiviral Agents, Antiretroviral Agents

Other Drugs in the Subclass, Nucleoside Analogues: Abacavir, Adefovir, Didanosine, Emtricitabine, Entecavir, Lamivudine, Telbivudine, Tenofovir, Zidovudine

## CASE REPORTS

### Case 1. Liver injury, hyperlactatemia and pancreatitis induced by stavudine.(1)

A 45 year old man with HIV infection developed nausea, vomiting and abdominal pain 3 months after starting stavudine (400 mg twice daily). He had been on didanosine (400 mg daily) and prednisone (5 mg daily) for more than 2 years and had previously received zidovudine. On physical examination, he was jaundiced and had right upper quadrant abdominal tenderness. Serum bilirubin was 14 mg/dL, alkaline phosphatase 400 U/L and ALT 300 U/L. Serum amylase levels were mildly elevated. Lactate levels were not measured. Abdominal ultrasound showed changes compatible with fatty liver and percutaneous liver biopsy revealed macrovesicular steatosis and cholestatic hepatitis. Both didanosine and stavudine were stopped. The patient improved, and all tests were normal 3 weeks later. After recovery, stavudine was restarted in the same dose and, within a week, serum lactate levels increased from normal to 9.1 mmol/L, but serum aminotransferase levels did not change. Stavudine was stopped again and the patient remained well off of all antiretroviral therapy and had normal serum enzymes over the next year.

#### Key Points

Medication: | Stavudine (40 mg twice daily)
Pattern: | Cholestatic (R=1.9)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3 months
Recovery: | 3 weeks
Other medications: | Prednisone 5 mg daily, didanosine 400 mg daily

#### Comment

Stavudine was considered to be the most likely cause of the liver injury and hyperlactatemia, although didanosine may have contributed or increased the risk. He had received didanosine without problems for the previous two years, the liver injury arising only with the addition of stavudine. This syndrome appears to be rapidly reversible with withdrawal of nucleoside analogue therapy in the early stages of hyperlactatemia and liver injury.

### Case 2. Fatal lactic acidosis and hepatic steatosis after stavudine therapy.(2)

A 45 year old woman with HIV infection developed worsening peripheral neuropathy followed by jaundice and severe abdominal pain 5 months after changing her antiretroviral regimen from zidovudine and didanosine to nevirapine, stavudine, lamivudine and hydroxyurea. On admission, physical examination showed dehydration, jaundice and abdominal tenderness with tachypnea and tachycardia. Serum bilirubin was 14.3 mg/dL, ALT 45 IU/L, alkaline phosphatase 835 IU/L, amylase 968 U/L, lactate 14.3 mmol/ L and arterial pH 7.26. Tests for hepatitis B and C were negative. Abdominal ultrasound showed pancreatic edema and echogenicity of the liver suggestive of steatosis. Liver biopsy showed steatosis and cholestasis. Despite intensive medical support, she developed intractable lactic acidosis and multiorgan failure, dying within 48 hours of admission.

#### Key Points

Medication: | Stavudine (400 mg twice daily)
Pattern: | Cholestatic (R<1)
Severity: | 5+ (fatal)
Latency: | 5 months
Recovery: | None
Other medications: | Nevirapine, lamivudine, hydroxyurea; previously zidovudine, didanosine

#### Comment

Five months after stavudine was added to a chronic antiretroviral regimen, this patient developed severe liver injury and lactic acidosis that was rapidly fatal. Symptoms of neuropathy had been present for several weeks and diagnosis was delayed until severe lactic acidosis was present. The mitochondrial injury from nucleoside analogues can affect liver, pancreas, muscle and peripheral nerves singly or in combination.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Stavudine – Generic, Zerit®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=stavudine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Stavudine | 3056-17-5 | C10-H12-N2-O4

## CITED REFERENCES

1 Bleeker-Rovers CP, Kadir S, van Leusen R, Richter C. (2000). Hepatic steatosis and lactic acidosis caused by stavudine in an HIV-infected patient. Neth J Med.
2 Cornejo-Juárez P, Sierra-Madero J, Volkow-Fernández P. (2003). Metabolic acidosis and hepatic steatosis in two HIV-infected patients of stavudine (d4T) treatment. Arch Med Res.

## ANNOTATED BIBLIOGRAPHY

References updated: 25 June 2020

Abbreviations used: AIDS, acquired immune deficiency syndrome; HBV, hepatitis B virus; HCV, hepatitis C virus; HIV, human immunodeficiency virus; HPA, hepatoportal sclerosis; HVPG, hepatic venous pressure gradient; mt, mitochondrial; NASH, nonalcoholic steatohepatitis; NCPH, noncirrhotic portal hypertension; NRH, nodular regenerative hyperplasia; TE, transient elastography.

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents including stavudine).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1137-58. (Textbook of pharmacology and therapeutics).
National Institutes of Health. http://aidsinfo.nih.gov/guidelines. (Clinical guidelines on the use of antiretroviral agents in HIV-1 infected adults, adolescents and children).
Freiman JP, Helfert KE, Hamrell MR, Stein DS. (1993). Hepatomegaly with severe steatosis in HIV-seropositive patients. AIDS. (Reports of 6 fatal and 2 nonfatal cases of hepatomegaly and steatosis in patients with HIV on zidovudine for 3-12 months).
Chattha G, Arieff AI, Cumings G, Tierney LM. (1993). Lactic acidosis complicating the acquired immunodeficiency syndrome. Ann Intern Med. (Report of 7 patients with HIV infection who developed lactic acidosis of unknown cause, presenting with nausea, anorexia and weight loss followed by dyspnea, stupor and death [in 4]; 4 on zidovudine, 1 ganciclovir and 1 clofazimine; initial arterial pH 7.09-7.27, lactate 10.4-17.4 mmol/L).
McKenzie R, Fried MW, Sallie R, Conjeevaram H, Di Bisceglie AM, Park Y, Savarese B, et al. (1995). Hepatic failure and lactic acidosis due to fialuridine(FIAU), an investigational nucleoside analogue for chronic hepatitis B. N Engl J Med. (Description of syndrome of lactic acidosis, hepatic failure and pancreatitis arising after 8-11 weeks of fialuridine treatment in 15 patients with chronic hepatitis B; among 7 patients affected, 5 died of intractable lactic acidosis and 2 survived, but required emergency liver transplantation).
Lewis W, Dalakas MC. (1995). Mitochondrial toxicity of antiviral drugs. Nat Med. (Review of mechanisms for mitochondrial injury by nucleoside analogues, including inhibition of mitochondrial DNA polymerase gamma).
Styrt B, Freiman JP. (1995). Hepatotoxicity of antiviral agents. Gastroenterol Clin North Am. (Early review of liver toxicity of antiviral agents, covering the first four nucleoside analogues used for HIV infection: zidovudine, didanosine, zalcitabine and stavudine).
Lenzo NP., Garas BA, French MA. (1997). Hepatic steatosis and lactic acidosis associated with stavudine treatment in an HIV patient: a case report. AIDS. (32 year old woman with HIV infection developed lactic acidosis and hepatic steatosis 6 months after starting stavudine with zidovudine and lamivudine [bilirubin 1.6 mg/dL, ALT 67 U/L], resolving rapidly upon stopping stavudine).
Schiano TD, Lissoos T, Ahmed A, Siano C, Zaitman D, Cohn G, Ehrenpreis E. (1997). Lamivudine-stavudine-induced liver failure in hepatitis B cirrhosis. Am J Gastroenterol. (69 year old man with HIV-HBV coinfection and cirrhosis developed flare of hepatitis beginning 2 weeks after adding lamivudine to long term stavudine [peak bilirubin 20.7 mg/dL, ALT 2414 U/L, ascites and pruritus], improving slowly once lamivudine was stopped; HBV DNA level was high, but timing and serial results were not given).
Zylberberg H, Pialoux G, Carnot F, Landau A, Bréchot C, Pol S. (1998). Rapidly evolving hepatitis C virus-related cirrhosis in a human immunodeficiency virus-infected patient receiving triple antiretroviral therapy. Clin Infect Dis. (36 year old woman with HIV-HCV coinfection developed ascites 9 months after starting lamivudine, indinavir and stavudine [bilirubin 2.1 mg/dL, ALT 60 U/L, Alk P 107 U/L], with subsequent liver failure; biopsy showed nodularity and “cirrhosis”).
Brinkman K, ter Hofstede HJ, Burger DM, Smeitink JAM, Koopmans PP. (1998). Adverse effects of reverse transcriptase inhibitors: mitochondrial toxicity as a common pathway. AIDS. (Review of mitochondrial function and role of mitochondrial toxicity or depletion in the adverse side effects of nucleoside analogues).
Finkle HI. (1999). Hepatic mitochondrial toxicity from nucleoside analog therapy. Arch Pathol Lab Med. (42 year old man with HIV infection developed lactic acidosis on combination therapy with stavudine and didanosine, with ALT 73 U/L, autopsy showing microvesicular steatosis).
Benveniste O, Longuet P, Duval X, Le Moing V, Leport C, Vildé JL. (1999). Two episodes of acute renal failure, rhabdomyolysis, and severe hepatitis in an AIDS patient successively treated with ritonavir and indinavir. Clin Infect Dis. (34 year old man with HIV-HCV coinfection developed fever and jaundice 6 days after starting ritonavir [bilirubin 12.3 mg/dL, ALT 491 U/L, creatinine 4.1 mg/dL], resolving with stopping and then tolerating indinavir, stavudine and lamivudine for 1 year when she presented with lactic acidosis and jaundice [bilirubin 10.2 mg/dL, ALT 234 U/L, CPK 3074 U/L], resolving again with stopping; unclear which agent[s] were responsible for second episode).
Allaouchiche B, Duflo F, Cotte L, Mathon L, Chassard D. (1999). Acute pancreatitis with severe lactic acidosis in an HIV-infected patient on didanosine therapy. J Antimicrob Chemother. (58 year old man with HIV infection developed abdominal pain and elevated amylase [1059 U/L] after treatment with didanosine, stavudine and indinavir [bilirubin 7.3 mg/dL, ALT 75 U/L, Alk P 107 U/L, lactate 13 mmol/L], resolving within 3 weeks of stopping).
Frippiat F, Derue G, Heller F, Honore P, Moreau M, Vandercam B. (2000). Acute pancreatitis associated with severe lactic acidosis in human immunodeficiency virus-infected patients receiving triple therapy. J Antimicrob Chemother. (Letter in response to Allaouchiche et al. suggesting that stavudine may have been the cause or contributed to the mitochondrial toxicity and pancreatitis).
Bleeker-Rovers CP, Kadir S, van Leusen R, Richter C. (2000). Hepatic steatosis and lactic acidosis caused by stavudine in an HIV-infected patient. Neth J Med. (45 year old man with HIV developed nausea and abdominal pain after 2 years of didanosine and 3 months of stavudine therapy [bilirubin 14.0 mg/dL, ALT 300 U/L, Alk P 400 U/L, no obvious acidosis], resolving slowly after stopping; rechallenge with stavudine resulted in rise in lactate levels within one week [9.1 mmol/L] and stavudine was stopped again: Case 1).
ter Hofstede HJ, de Marie S, Foudraine NA, Danner SA, Brinkman K. (2000). Clinical features and risk factors of lactic acidosis following long-term antiretroviral therapy: 4 fatal cases. Int J STD AIDS. (Four patients on stavudine [3 on didanosine as well] for 6-18 months developed fatal lactic acidosis, presenting with nausea, abdominal pain and weight loss [pH 7.04-7.17]; autopsies in 2 showed severe hepatomegaly, micro- and macro-steatosis, and cholestasis).
Gérard Y, Maulin L, Yazdanpanah Y, De La Tribonnière X, Amiel C, Maurage CA, Robin S, et al. (2000). Symptomatic hyperlactataemia: an emerging complication of antiretroviral therapy. AIDS. (Identified 14 patients with symptoms of elevated lactate [levels 0.9 to 9.4 mmol/L] with fatigue, abdominal pain, weight loss, neuropathy and dyspnea on exertion, all on stavudine [9 also on didanosine] for 2-29 months).
Brivet FG, Nion I, Mégarbane B, Slama A, Brivet M, Rustin P, Munnich A. (2000). Fatal lactic acidosis and liver steatosis associated with didanosine and stavudine treatment: a respiratory chain dysfunction?. J Hepatol. (Patient with HIV infection on didanosine and stavudine for 9 months developed nausea and anorexia [bilirubin 1.2 mg/dL, ALT 206 U/L and progressive lactic acidosis] leading to death 5 days later; autopsy showed pancreatitis and hepatomegaly with severe macrovesicular steatosis).
Carr A, Miller J, Law M, Cooper DA. (2000). A syndrome of lipoatrophy, lactic acidemia and liver dysfunction associated with HIV nucleoside analogue therapy: contribution to protease inhibitor related syndrome. AIDS. (Description of 14 patients who developed lipodystrophy on antiretroviral therapy, who never received protease inhibitors, but had received stavudine [86%] or didanosine [71%] for >6 months and most had hyperlactatemia, ALT elevations and weight loss, nausea and fatigue and resolved slowly upon withdrawal).
Gisolf EH, Dreezen C, Danner S, Weel JL, Weverling GJ, Prometheus Study Group. (2000). Risk factors for hepatotoxicity in HIV-1 infected patients receiving ritonavir and saquinavir with or without stavudine. Clin Infect Dis. (Among 218 patients with HIV infection starting antiretroviral therapy, 18 [9%] developed liver enzyme elevations after an average of 12 weeks [ALT 150 to 1890 U/L]; risk factors were HBV coinfection and stavudine use).
Sulkowski MS, Thomas DL, Chaisson RE, Moore RD. (2000). Hepatotoxicity associated with antiretroviral therapy in adults infected with human immunodeficiency virus and the role of hepatitis C or B virus infection. JAMA. (Among 298 patients with HIV infection, ALT elevations above 5 times ULN occurred in 10.4% per year during antiretroviral treatment; factors associated with ALT elevations included ritonavir [27.3%] and coinfection with either HCV or HBV; ALT with bilirubin elevations occurred in 3 patients; 2 on indinavir and all 3 with coinfection).
Velasco M, Guijarro C. (2000). Elevated liver enzymes following initiation of antiretroviral therapy. JAMA. (Letter in response to Sulkowski et al. [JAMA 2000] pointing out that antiretroviral therapy can cause immune reconstitution and flares of hepatitis B or C, which may be misdiagnosed as hepatotoxicity).
Sulkowski MS, Thomas DL, Chaisson RE, Moore RD. (2000). Elevated liver enzymes following initiation of antiretroviral therapy. JAMA. (Reply to Velasco and Guijarro pointing at that the majority of the ALT elevations described could not be attributed to immune reconstitution).
Johri S, Alkhuja S, Siviglia G, Soni A. (2000). Steatosis-lactic acidosis syndrome associated with stavudine and lamivudine therapy. AIDS. (Three women, ages 36 to 40 years, with HIV infection developed lactic acidosis and hepatic steatosis 1-8 months after starting stavudine and lamivudine [AST 291, 48 and 119 U/L, severe acidosis, and fatty liver by imaging]; two died, one of whom had massive hepatomegaly and steatosis on autopsy).
Lonergan JT, Behling C, Pfander H, Hassanein TI, Mathews WC. (2000). Hyperlactatemia and hepatic abnormalities in 10 human immunodeficiency virus-infected patients receiving nucleoside analogue combination regimens. Clin Infect Dis. (Over a 6 month period, authors identified 10 HIV-positive patients with high lactate levels [2.9-6.2 mmol/L]; all 10 were taking stavudine, 5 didanosine and 7 lamivudine for 4-20 months; 8 had symptoms of abdominal pain, nausea or distension; all 20 had ALT elevations [2-10.7 times ULN], 3 with HBV or HCV; imaging showed fatty liver in 5; all resolved with stopping, lactate levels falling to normal after 16-111 days).
Miller KD, Cameron M, Wood LV, Dalakas MC, Kovacs JA. (2000). Lactic acidosis and hepatic steatosis associated with use of stavudine: report of four cases. Ann Intern Med. (2 women and 2 men with HIV infection, ages 15 months to 63 years, developed hepatic steatosis and lactic acidosis 3, 6, 15 and 15 months after starting stavudine [bilirubin not mentioned, ALT 43-356 U/L, elevated lactates 4.3-13.6 mmol/L, fatty liver on imaging], two had liver biopsies showing severe steatosis, all resolved with medical support and stopping stavudine).
Mokrzycki MH, Harris C, May H, Laut J, Palmisano J. (2000). Lactic acidosis associated with stavudine administration: a report of five cases. Clin Infect Dis. (4 women and one man with HIV infection developed lactic acidosis and hepatic steatosis 1-12 months after starting stavudine;1 died of pancreatitis, 4 recovered in 4-60 weeks; 2 cases described in detail [bilirubin 0.7 and 2.0 mg/dL, ALT 43 and 41 U/L, Alk P 46 and 41 U/L]).
Claessens Y-E, Cariou A, Chiche J-D, Dauriat G, Dhainaut J-F. (2000). L-carnitine as a treatment of life-threatening lactic acidosis induced by nucleoside analogues. AIDS. (34 year old man developed abdominal pain and nausea 11 months after starting stavudine, didanosine and saquinavir with severe lactic acidosis, cholestasis and fatty liver; given intravenous l-carnitine and slowly recovered).
John M, Moore CB, James IR, Nolan D, Upton RP, McKinnon EJ, Mallal SA. (2001). Chronic hyperlactatemia in HIV-infected patients taking antiretroviral therapy. AIDS. (349 patients with HIV infection were screened for lactate levels on multiple occasions; 2 on stavudine had symptomatic lactic acidosis, estimated incidence of 3.9 per 1000 person years).
Coghlan ME, Sommadossi JP, Jhala NC, Many WJ, Saag MS, Johnson VA. (2001). Symptomatic lactic acidosis in hospitalized antiretroviral-treated patients with human immunodeficiency virus infection: a report of 12 cases. Clin Infect Dis. (Experience with 12 cases of lactic acidosis in patients with HIV infection seen over 6 years, typically with anorexia, nausea and weight loss for several weeks, AST variably elevated, 11 on stavudine, 9 didanosine, 1 zidovudine alone; 6 with pancreatitis, 6 having liver biopsies all showed macro- and micro-steatosis; five died).
Boubaker K, Flepp M, Sudre P, Furrer H, Haensel A, Hirschel B, Boggian K, et al. (2001). Hyperlactatemia and antiretroviral therapy: the Swiss HIV Cohort Study. Clin Infect Dis. (Cross sectional analysis of lactate testing on 880 Swiss patients with HIV receiving antiretroviral therapy; elevated levels were associated with stavudine and didanosine use and with lipodystrophy [and high glucose and triglycerides] but not with age, sex, CD4 counts or HIV RNA levels).
Carr A, Morey A, Mallon P, Williams D, Thorburn DR. (2001). Fatal portal hypertension, liver failure, and mitochondrial dysfunction after HIV-1 nucleoside analogue-induced hepatitis and lactic acidaemia. Lancet. (65 year old man developed hyperlactatemia and ascites 14 months after starting didanosine and stavudine [lactate 7 mmol/L, no acidosis, ALT 181 U/L], recovering slowly after stopping, but presenting 1 year later with signs of portal hypertension, ascites, encephalopathy and varices; biopsy did not show cirrhosis; possibly nodular regenerative hyperplasia).
Côté HC, Brumme ZL, Craib KJ, Alexander CS, Wynhoven B, Ting L, Wong H, et al. (2002). Changes in mitochondrial DNA as a marker of nucleoside toxicity in HIV-infected patients. N Engl J Med. (High serum lactate levels were associated with low ratio of mitochondrial to nuclear DNA in peripheral blood mononuclear cells from patients with HIV on stavudine and other agents).
Moyle GJ, Datta D, Mandalia S, Morlese J, Asboe D, Gazzard BG. (2002). Hyperlactataemia and lactic acidosis during antiretroviral therapy: relevance, reproducibility and possible risk factors. AIDS. (Retrospective analysis of results of testing for lactate levels in 1239 patients with HIV infection, 108 [9%] had elevated levels >2.5 mmol/L and 9 [1%] >5 mmol/L of whom 4 had lactic acidosis and 2 died; in multivariate analysis, elevations were associated with didanosine use and female sex).
Hillaire S, Bonte E, Denninger MH, Casadevall N, Cadranel JF, Lebrec D, Valla D, et al. (2002). Idiopathic non-cirrhotic intrahepatic portal hypertension in the West: a re-evaluation in 28 patients. Gut. (Among 28 cases of NCPH diagnosed between 1994 and 1998, none were diagnosed with HIV infection and no discussion of drug relatedness; 12 had a prothrombotic disorder).
Dybul M, Fauci AS, Bartlett JG, Kaplan JE, Pau AK, Panel on Clinical Practices for the Treatment of HIV. (2002). Guidelines for using antiretroviral agents among HIV-infected adults and adolescents. Recommendations of the Panel on Clinical Practices for Treatment of HIV. MMWR Recomm Rep. (Recommendations on use of antiretroviral agents for HIV infection including indications, efficacy, need for monitoring and side effects including hepatotoxicity).
Lemberg DA, Palasanthiran P, Goode M, Ziegler JB. (2002). Tolerabilities of antiretrovirals in paediatric HIV infection. Drug Saf. (Review of adverse events for the antiretrovirals in children; rates of hepatotoxicity appear to be similar in children as adults, mitochondrial toxicity is rare, but deaths due to pancreatitis and liver failure have been reported in children on didanosine).
Cihlar T, Birkus G, Greenwalt DE, Hitchcock MJM. (2002). Tenofovir exhibits low cytotoxicity in various human cell types: comparison with other nucleotide reverse transcriptase inhibitors. Antiviral Research. (Study to evaluate the in vitro effects of nucleoside analogues in various human cell types; tenofovir was less cytotoxic towards erythroid progenitor cells than zidovudine, stavudine, and zalcitabine).
Falcó V, Rodríguez D, Ribera E, Martínez E, Miró JM, Domingo P, Diazaraque R, et al. (2002). Severe nucleoside-associated lactic acidosis in human immunodeficiency virus-infected patients: report of 12 cases and review of the literature. Clin Infect Dis. (Between 1997-2000, 12 cases of lactic acidosis were reported in HIV-infected patients at 4 hospitals in Spain; ~1:1000 patient-years of treatment; all receiving nucleoside analogues for 1-36 months, 1 attributed to zidovudine, 11 to stavudine [1 also on didanosine] with ALT 30-524 U/L, 33% fatality rate).
Clark SJ, Creighton S, Portmann B, Taylor C, Wendon JA, Cramp ME. (2002). Acute liver failure associated with antiretroviral treatment for HIV: a report of six cases. J Hepatol. (6 patients with HIV infection who developed acute liver failure on stavudine [n=5], lamivudine [n=3], didanosine [n=2], saquinavir [n=2], efavirenz [n=2], nevirapine [n=2], or nelfinavir, delavirdine or zidovudine [n=1] for 1-3 months [peak bilirubin 2.7-32 mg/dL, AST 240-8650 U/L, Alk P 122-191 U/L]; 2 with signs of hypersensitivity; 2 with hepatitis B; 5 died, autopsies showing massive necrosis, one with massive steatosis, likely multiple causes).
Spengler U, Lichterfeld M, Rockstroh JK. (2002). Antiretroviral drug toxicity—a challenge for the hepatologist?. J Hepatol. (Review of the diagnosis of drug induced liver disease in patients with HIV on antiretroviral agents, with discussion of mechanisms including mitochondrial toxicity and hypersensitivity reactions).
Cornejo-Juárez P, Sierra-Madero J, Volkow-Fernández P. (2003). Metabolic acidosis and hepatic steatosis in two HIV-infected patients of stavudine (d4T) treatment. Arch Med Res. (1 woman and 1 man developed fatigue and jaundice 5 and 1 months after switching to an antiretroviral regimen that included stavudine [bilirubin 14.3 and 27.0 mg/dL, ALT 45 and 62 U/L, Alk P 835 and 296 U/L] with lactic acidosis, hepatic steatosis and fatal outcome: Case 2).
Koch RO, Graziadel IW, Zangerle R, Romani N, Maier H, Vogel W. (2003). Acute hepatic failure and lactic acidosis associated with antiretroviral treatment for HIV. Wien Klin Wochenschr. (36 year old woman with HIV infection developed nausea and abdominal pain 18 months after starting didanosine and stavudine [bilirubin 1.2 rising to 12.0 mg/dL, ALT 40 to 177 U/L], developing pancreatitis, lactic acidosis, hepatic encephalopathy and ascites, recovering slowly upon stopping drugs, liver biopsy showed microvesicular fat and cholestasis with little inflammation).
Lonergan JT, Barber RE, Mathews WC. (2003). Safety and efficacy of switching to alternative nucleoside analogues following symptomatic hyperlactatemia and lactic acidosis. AIDS. (Description of 12 patients with HIV infection on antiretrovirals who developed hyperlactatemia >5 mmol/L [2 with acidosis; all on stavudine], improving upon stopping therapy, and restarting nucleosides without stavudine was tolerated in all but one case [on zidovudine] who later tolerated lamivudine and abacavir).
Manfredi R, Motta R, Patrono D, Calza L, Chiodo F, Boni P. (2003). Frequency, risk factors and features of hyperlactatemia in a large number of patients undergoing antiretroviral therapy. AIDS. (High lactate level found at least once in 36% of 743 HIV infected patients on antiretroviral therapy; few distinguishing characteristics from those who did not develop high lactates, longer duration of therapy and concurrent lipodystrophy or myopathy).
Kontorinis N, Dieterich D. (2003). Hepatotoxicity of antiretroviral therapy. AIDS Rev. (Review of hepatotoxicity of antiretroviral drugs; definition of hepatotoxicity in antiretroviral studies; grade 1=1.25-2.5 times, grade 2=2.6-5 times, grade 3=5.1-10 times and grade 4=>10 times normal or baseline ALT values; abacavir and lamivudine are least likely to cause hepatotoxicity).
Ogedegbe AE, Thomas DL, Diehl AM. (2003). Hyperlactataemia syndromes associated with HIV therapy. Lancet Infect Dis. (Review of mechanisms of hyperlactatemia with antiretroviral therapy, occurs mostly with use of nucleoside analogues, stavudine, didanosine and zidovudine, attributed to mitochondrial depletion, but other mechanisms may be involved).
Rivas P, Polo J, de Górgolas M, Fernández-Guerrero ML. (2003). Drug points: Fatal lactic acidosis associated with tenofovir. BMJ. (45 year old woman with HIV-HCV coinfection on didanosine, stavudine, and nevirapine developed jaundice and hepatomegaly after switching from nevirapine to tenofovir [bilirubin 12.6 mg/dL, ALT 157 U/L, CT showing fatty liver] and had worsening lactic acidosis despite medical support, and she died 36 hours after presentation).
Gérard Y, Viget N, Yazdanpanah Y, Ajana F, de La Tribonnière X, Bocket L, Deuffic-Burban S, et al. (2003). Hyperlactataemia during antiretroviral therapy: incidences, clinical data and treatment. Therapie. (Prospective study identified 64 patients with high lactate levels [18/1000 person-years], 10 with lactic acidosis [lactate 5.0-16 mmol/L, ALT 25-122 U/L], all receiving stavudine, one died).
Verucchi G, Calza L, Manfredi R, Chiodo F. (2003). Incidence of liver toxicity in HIV-infected patients receiving isolated dual nucleoside analogue antiretroviral therapy. J Acquir Immune Defic Syndr. (Retrospective analysis of 132 patients with HIV infection treated with two nucleoside analogues for at least 24 months; 52% developed ALT elevation, 6% >5 times ULN, only 1 with jaundice requiring discontinuation; higher rates in patients with HIV-HCV coinfection and with stavudine).
Lichterfeld M, Fischer HP, Spengler U, Rockstroh JK. (2003). Dtsch Med Wochenschr. (50 year old developed abdominal pain and hepatomegaly 7 months after starting stavudine, lamivudine, indinavir and low dose ritonavir [ALT 434 U/L, GGT 58 U/L, lactate 9.2 mmol/L, pH 7.2], liver biopsy showing micro- and macro-steatosis, resolving a few weeks after stopping antivirals; most likely due to stavudine).
Ofotokun I, Pomeroy C. (2003). Sex differences in adverse reactions to antiretroviral drugs. Top HIV Med. (Review of sex differences in adverse events; higher frequency of mitochondrial toxicity and hypersensitivity in women than men).
Ogedegbe AO, Sulkowski MS. (2003). Antiretroviral-associated liver injury. Clin Liver Dis. (Review of hepatotoxicity of antiretrovirals; ALT elevations above 5 times ULN reported in 7% with zidovudine, 16% didanosine, 9-13% stavudine, <1% lamivudine, tenofovir and abacavir, 3-10% protease inhibitors, 10% nevirapine and 8% efavirenz; recommend monitoring at 4 weeks and then every 12 weeks, stopping if ALT levels are >10 times ULN or if symptoms of liver injury are present, monitoring more closely if ALT levels are elevated).
Bonnet F, Bonarek M, Morlat P, Mercie P, Dupon M, Gemain MC, Malvy D, et al. (2003). Risk factors for lactic acidosis in HIV-1-infected patients treated with nucleoside reverse-transcriptase inhibitors: a case-control study. Clin Infect Dis. (Case control study of 9 patients [5 women] with HIV infection and lactic acidosis, 6 with hepatomegaly and 5 with jaundice, 8 on stavudine, 7 on didanosine, 6 on zidovudine; 6 died; risk factors were renal insufficiency and low CD4 counts, but numbers of cases were few).
Arenas-Pinto A, Grant AD, Edwards S, Weller IVD. (2003). Lactic acidosis in HIV-1 infected patients: a systematic review of published cases. Sex Transm Infect. (Review of 217 published cases of lactic acidosis; 53% female, all taking at least one nucleoside for 1-36 months, 61% on stavudine, 33% didanosine, 31% zidovudine, 30% lamivudine; 92% had hepatic steatosis on biopsy or autopsy; 48% died).
Lonergan JT, McComsey GA, Fisher RL, Shalit P, File TM, Ward DJ, Williams VC, et al., ESS40010 (TARHEEL) Study Team. (2004). Lack of recurrence of hyperlactatemia in HIV-infected patients switched from stavudine to abacavir or zidovudine. J Acquir Immune Defic Syndr. (Prospective study of 118 patients with HIV infection on stavudine switched to abacavir or zidovudine, lactate levels fell with stopping stavudine and despite starting other agents; few were markedly hyperlactatemic).
Gallant JE, Staszewski S, Pozniak AL, DeJesus E, Suleiman JM, Miller MD, Coakley DF, et al. (2004). for the 903 Study Group. Efficacy and safety of tenofovir DF vs stavudine in combination therapy in antiretroviral-naïve patients: a 3-year randomized trial. JAMA. (Controlled trial of 3 years of tenofovir vs stavudine added to lamivudine and efavirenz in 600 treatment-naïve patients with HIV infection; ALT rises above 5 times normal in 4% of tenofovir- vs 5% of stavudine-treated; lactic acidosis in no tenofovir- vs 3 [1%] stavudine-treated subjects).
Montaner JS, Côté HC, Harris M, Hogg RS, Yip B, Harrigan PR, O'Shaughnessy MV. (2004). Nucleoside-related mitochondrial toxicity among HIV-infected patients receiving antiretroviral therapy: insights from the evaluation of venous lactic acid and peripheral blood mitochondrial DNA. Clin Infect Dis. (Review of issue of mitochondrial [mt] toxicity of nucleoside analogues in antiretroviral therapy; random testing for venous lactate levels identifies some patients with symptoms of mt toxicity, but does not predict severe lactic acidosis; mtDNA to nuclear DNA ratios in peripheral blood mononuclear cells correlates with hyperlactaemia and mt toxicity; ratios were lower in HIV-infected and in stavudine-treated subjects).
Walker UA, Bäuerle J, Laguno M, Murillas J, Mauss S, Schmutz G, Setzer B, et al. (2004). Depletion of mitochondrial DNA in liver under antiretroviral therapy with didanosine, stavudine, or zalcitabine. Hepatology. (Liver biopsies from 94 patients with chronic HCV [80 with concurrent HIV] were assessed for mitochondrial DNA content, which were 50% lower in patients on zalcitabine, didanosine, or stavudine compared to other nucleoside analogues; the decrease required 6 months or more of therapy).
Pujari SN, Patel AK, Naik E, Patel KK, Dravid A, Patel JK, Mane AA, et al. (2004). Effectiveness of generic fixed-dose combinations of highly active antiretroviral therapy for treatment of HIV infection in India. J Acquir Immune Defic Syndr. (Analysis of 1291 patients started on nevirapine based combination regimens in India; rash in 6.6% and hepatitis in 3.2%, but no deaths from liver injury except 4 with lactic acidosis on stavudine).
Te HS. (2004). Cholestasis in HIV-infected patients. Clin Liver Dis. (Review of causes of cholestasis in HIV-infected patients including antiretrovirals).
Verucchi G, Calza L, Biagetti C, Attard L, Costigliola P, Manfredi R, Pasquinelli G, et al. (2004). Ultrastructural liver mitochondrial abnormalities in HIV/HCV-coinfected patients receiving antiretroviral therapy. J Acquir Immune Defic Syndr. (Electron microscopy of 34 liver biopsies done on HIV-HCV coinfected patients on long term antiretroviral therapy [2-14 years] and in 4 on no therapy found mitochondrial abnormalities in all except 1, but not associated with a specific agent and unclear whether due to therapy, HCV, HIV or other factors).
Abrescia N, D’Abbraccio M, Figoni M, Busto A, Maddaloni A, De Marco M. (2005). Hepatotoxicity of antiretroviral drugs. Curr Pharm Des. (Review of hepatotoxicity of antiretrovirals; major syndrome is mitochondrial injury with lactic acidosis and severe hepatomegaly and steatosis).
Torti C, Lapadula G, Casari S, Puoti M, Nelson M, Quiros-Roldan E, Bella D, et al., EPOKA-MASTER Study Group. (2005). Incidence and risk factors for liver enzyme elevation during highly active antiretroviral therapy in HIV-HCV co-infected patients: results from the Italian EPOKA-MASTER Cohort. BMC Infect Dis. (Among 1038 HIV-HCV coinfected patients starting antiretroviral therapy, the risk of ALT elevations above 5 times ULN was 17.1/100 patient years in treatment-naïve and 8.2 in treatment-experienced group; risk factors being baseline ALT levels and use of nonnucleoside reverse transcriptase inhibitors).
Sulkowski MS, Mehta SH, Torbenson M, Afdhal NH, Mirel L, Moore RD, Thomas DL. (2005). Hepatic steatosis and antiretroviral drug use among adults coinfected with HIV and hepatitis C virus. AIDS. (Analysis of liver histology from 112 patients with HIV-HCV coinfection; 40% had some degree of steatosis [>5% of hepatocytes with fat] which was independently associated with white race, body weight, high blood sugar and ever having used stavudine).
Hofman P, Nelson AM. (2006). The pathology induced by highly active antiretroviral therapy against human immunodeficiency virus: an update. Curr Med Chem. (Review of pathology of adverse effects of antiretroviral agents with examples of mitochondrial liver injury and cholestasis).
Núñez M. (2006). Hepatotoxicity of antiretrovirals: incidence, mechanisms and management. J Hepatol. (Review of hepatotoxicity of antiretrovirals; elevations in ALT or AST above 5 times ULN occurs in 2-18% of HIV-positive patients starting therapy, more frequent with HCV or HBV coinfection; combination of protease inhibitors with low dose ritonavir does not seem to increase risk; agents with highest risk are nevirapine and the nonnucleoside reverse transcriptase inhibitors).
Björnsson E, Olsson R. (2006). Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis. (In WHO database of fatal adverse drug reactions from 1968-2003, there were 4690 reports of fatal drug induced injury: stavudine was ranked the 4th most common cause [~120 cases]).
Labarga P, Soriano V, Vispo ME, Pinilla J, Martin-Carbonero L, Castellares C, Casado R, et al. (2007). Hepatotoxicity of antiretroviral drugs is reduced after successful treatment of chronic hepatitis C in HIV-infected patients. J Infect Dis. (Among 133 patients with HIV-HCV coinfection who were treated with interferon or peginterferon, 33% had a sustained response and subsequent yearly rate of hepatic events was higher among nonresponders [12.9%] than responders [3.1%]; also more common with receipt of di-deoxynucleosides).
Lapadula G, Izzo I, Costarelli S, Cologni G, Bercich L, Casari S, Gambarotti M, et al. (2007). Dideoxynucleoside HIV reverse transcriptase inhibitors and drug-related hepatotoxicity: a case report. J Med Case Rep. (43 year old woman with HIV and AIDS had elevations in ALT [222 U/L] while on stavudine and tenofovir for 2.8 years and indinavir and ritonavir for 5 months; worsening [ALT 353 U/L] despite stopping indinavir; liver biopsy showed micro- and macrovesicular fat and fibrosis; ALT improved after stopping stavudine despite remaining on tenofovir, lamivudine and nelfinavir).
Bourlière M, Duclos-Vallée JC, Pol S. (2007). Gastroenterol Clin Biol. (Review of hepatotoxicity of antiretrovirals in French discussing patterns of toxic idiosyncrasy, hypersensitivity [nevirapine and abacavir], mitochondrial toxicity [zalcitabine, didanosine, stavudine and zidovudine], steatohepatitis [protease inhibitors with lipodystrophy], immune restoration [in patients with HIV-HBV or -HCV coinfection]; recommendations for management focusing on prevention and monitoring).
Esser S, Helbig D, Hillen U, Dissemond J, Grabbe S. (2007). Side effects of HIV therapy. J Dtsch Dermatol Ges. (Review of side effects of antiretroviral agents focusing on immune reconstitution syndrome, lipodystrophy, cutaneous skin reactions, hypersensitivity reactions [abacavir, nevirapine], hyperbilirubinemia [indinavir, atazanavir], local reactions [enfuvirtide], and hyperpigmentation [zidovudine, emtricitabine]).
Gil ACM, Lorenzetti R, Mendes GB, Marcillo AM, Toro AADC, da Silva MTN, dos Santos Vilela MM. (2007). Hepatotoxicity in HIV-infected children and adolescents on antiretroviral therapy. Sao Paulo Med J. (Retrospective analysis in 152 children [ages 1 to 18 years] with HIV infection on antiretroviral therapy; only 14 [10%] had ALT elevations and all were less than 5 times ULN; 4 on antituberculosis therapy; rarely used nonnucleoside reverse transcriptase inhibitors).
Jain MK. (2007). Drug-induced liver injury associated with HIV medications. Clin Liver Dis. (Review of hepatotoxicity of antiretroviral medications; ALT elevations occur in 2-18% of patients, but often resolve spontaneously even without dose modification; classes of injury include hypersensitivity [nevirapine, efavirenz, abacavir], mitochondrial injury [stavudine, didanosine, zidovudine], flares of hepatitis B [lamivudine, emtricitabine, tenofovir], flares of hepatitis C [any potent regimen], idiosyncratic injury [ritonavir, nevirapine, efavirenz], cholestatic hepatitis [many agents]).
Wester CW, Okezie OA, Thomas AM, Bussmann H, Moyo S, Muzenda T, Makhema J, et al. (2007). Higher-than-expected rates of lactic acidosis among highly active antiretroviral therapy-treated women in Botswana: preliminary results from a large randomized clinical trial. J Acquir Immune Defic Syndr. (Among 650 patients starting antiretroviral therapy, 2% developed hyperlactaemia [>4.4 mmol/L] and 1% lactic acidosis [all female, trend towards older age and higher body mass index] all on stavudine, didanosine, and/or zidovudine; 6 died, 4 of pancreatitis).
Songa PM, Castelnuovo B, Birabwa E, Ocama P, Kambugu A. (2007). Symptomatic hyperlactatemia associated with nucleoside analogue reverse-transcriptase inhibitor use in HIV-infected patients: a report of 24 cases in a resource-limited setting (Uganda). Clin Infect Dis. (Identified 24 patients with symptomatic hyperlactatemia, all on combination therapy including stavudine for 7 to 36 months, 83% women, 83% had neuropathy, weight loss common–2 to 18 kilograms; lactate 3.3 to 21.8 mmol/L, ALT and AST minimally elevated, 5 died).
Bolhaar MG, Karstaedt AS. (2007). A high incidence of lactic acidosis and symptomatic hyperlactatemia in women receiving highly active antiretroviral therapy in Soweto, South Africa. Clin Infect Dis. (Among 1735 adults with HIV infection started on antiretroviral therapy, 3% developed hyperlactatemia; 23 [1%] with lactic acidosis [22 women and 22 on stavudine, 1 on didanosine and zidovudine], 30% mortality; 44 had symptomatic hyperlactatemia [37 women, all 44 on stavudine, 3 also with didanosine], able to switch to zidovudine without recurrence, 2 of 3 relapsed on restarting stavudine).
Lactic Acidosis International Study Group. (2007). Risk factors for lactic acidosis and severe hyperlactataemia in HIV-1-infected adults exposed to antiretroviral therapy. AIDS. (Retrospective case control study of 110 cases of patients with HIV and hyperlactataemia and 220 controls, identified risk factors of older age, female gender, low CD4 counts, and use of stavudine, didanosine or both).
Mussi-Pinhata MM, Rego MA, Freimanis L, Kakehasi FM, Machado DM, Cardoso EM, Read JS, NISDI Perinatal Protocol Study Group. (2007). Maternal antiretrovirals and hepatic enzyme, hematologic abnormalities among human immunodeficiency virus type 1-uninfected infants: the NISDI perinatal study. Pediatr Infect Dis J. (Liver enzyme elevations in newborns of HIV infected mothers on various antiretroviral regimens; infants whose mothers received protease inhibitors were more likely to have ALT elevations [odds ratio 1.9] similarly for nonnucleoside reverse transcriptase inhibitors [odds ratio 2.4], most elevations were mild and self-limited).
Mallet V, Blanchard P, Verkarre V, Vallet-Pichard A, Fontaine H, Lascoux-Combe C, Pol S. (2007). Nodular regenerative hyperplasia is a new cause of chronic liver disease in HIV-infected patients. AIDS. (Among 8 patients with HIV infection referred for evaluation of liver disease of unknown cause, all had nodular regenerative hyperplasia and had received didanosine [and many received stavudine or zidovudine] for 1-2 years [bilirubin 0.2-2.0 mg/dL, ALT 0.4-2.0 times ULN, Alk P 0.9-19.1 times ULN, platelets 71-149,000/μL], all had varices and 5 had ascites).
Rosenthal E, Pialoux G, Bernard N, Pradler C, Rey D, Bentata M, Michelet C, et al., GERMIVIC Joint Study Group. (2007). Liver-related mortality in human-immunodeficiency-virus-infected patients between 1995 and 2003 in the French GERMIVIC Joint Study Group Network (MORTAVIC 2003 Study). J Viral Hepat. (A rising proportion of deaths among HIV infected patients in France were due to end stage liver disease: 1.5% in 1995, 6.6% in 1997, 14.3% in 2001, and 12.6% in 2003, HCV being the major cause [93%] and high alcohol intake [26%]).
Bae WH, Wester C, Smeaton LM, Shapiro RL, Lockman S, Onyait K, Thior I, et al. (2008). Hematologic and hepatic toxicities associated with antenatal and postnatal exposure to maternal highly active antiretroviral therapy among infants. AIDS. (Prospective monitoring found that only 1 of 69 infants born to antiretroviral-treated mothers and none of 109 infants born to drug therapy unexposed mothers with HIV infection developed ALT elevations >5 times ULN during the first 7 months of life).
Hammer SM, Eron JJ, Reiss P, Schooley RT, Thompson MA, Walmsley S, Cahn P, et al., International AIDS Society-USA. (2008). Antiretroviral treatment of adult HIV infection: 2008 recommendations of the International AIDS Society-USA panel. JAMA. (Recommendations on use of antiviral therapy in adults with HIV infection including use of recently approved agents: raltegravir, maraviroc and etravirine).
Inductivo-Yu I, Bonacini M. (2008). Highly active antiretroviral therapy-induced liver injury. Current Drug Safety. (Review of drug induced liver injury due to antiretroviral agents).
Saifee S, Joelson D, Braude J, Shrestha R, Johnson M, Sellers M, Galambos MR, et al. (2008). Noncirrhotic portal hypertension in patients with human immunodeficiency virus-1 infection. Clin Gastroenterol Hepatol. (Among 11 patients with HIV presenting with NCPH [mean bilirubin 1.2 mg/dL, ALT 53 U/L, ALK P 226 U/L, Platelet count 177,000/µL], 6 had protein S deficiency, all had received didanosine, all had NRH, 3 had portal venopathy, all had esophageal varices, 3 with bleeding, 6 with ascites and 2 requiring porto-systemic stent shunts).
Jevtović Dj, Ranin J, Salemović D, Pesić I, Dragović G, Zerjav S, Djurković-Djaković O. (2008). The prevalence and risk of hepatitis flares in a Serbian cohort of HIV and HCV co-infected patients treated with HAART. Biomed Pharmacother. (Among 364 HIV-infected patients treated with antiretrovirals in Belgrade between 1998-2006, 24 [7%] developed ALT elevations >5 times ULN [mostly asymptomatic], risk factors being HCV [21%] and use of stavudine and saquinavir/ritonavir).
Akhtar MA, Mathieson K, Arey B, Post J, Prevette R, Hillier A, Patel P, et al. (2008). Hepatic histopathology and clinical characteristics associated with antiretroviral therapy in HIV patients without viral hepatitis. Eur J Gastroenterol Hepatol. (23 patients with HIV infection without HBV or HCV coinfection with abnormal liver tests; attributed to antiretroviral agents in 17 [74%]; fatty liver was common).
Thoden J, Lebrecht D, Venhoff N, Neumann J, Muller K, Walker UA. (2008). Highly active antiretroviral HIV therapy-associated fatal lactic acidosis: quantitative and qualitative mitochondrial DNA lesions with mitochondrial dysfunction in multiple organs. AIDS. (62 year old man developed hyperlactatemia [3.7 mmol/L] without acidosis or symptoms 16 months after starting didanosine-stavudine-efavirenz, 2 months later developed fatal lactic acidosis and multiorgan failure; mitochondrial copy numbers assessed in multiple organs being reduced to 7% of normal levels in liver, 20% in kidney, 28% in muscle and 72% in heart).
Castelnuovo B, Nanyonjo A, Kamya M, Ocama P. (2008). Is it safe to switch from stavudine to zidovudine after developing symptomatic hyperlactatemia?. Afr Health Sci. (60 year old woman developed symptomatic lactatemia 19 months after starting stavudine, lamivudine and nevirapine; switching to zidovudine was followed by fall of lactate levels to normal [5.2→1.6 mmol/L], but 10 months later levels rose again [3.7 mmol/L]).
Fabian J, Venter WD, Mkhabela L, Levin JB, Baker L, Naicker S. (2008). Symptomatic hyperlactataemia in adults on antiretroviral therapy: a single-centre experience. S Afr Med J. (Retrospective analysis of 2587 adults with HIV infection started on antiretroviral therapy; 35 developed serum lactate levels >5 mmol/L, all of whom were on stavudine for 2-13 months, 86% females, 37% had neuropathy, most had weight loss, 7 died).
Stead D, Osler M, Boulle A, Rebe K, Meintjes G. (2008). Severe hyperlactataemia complicating stavudine first-line antiretroviral therapy in South Africa. Antivir Ther. (Retrospective analysis of 75 patients with HIV infection and symptomatic hyperlactatemia; 95% were women, all on stavudine [1.7 per 100 patient-years], 71% with lactic acidosis, 12 died; 30 switched to zidovudine without recurrence).
Nelson M, Azwa A, Sokwala A, Harania RS, Stebbing J. (2008). Fanconi syndrome and lactic acidosis associated with stavudine and lamivudine therapy. AIDS. (42 year old woman developed lactic acidosis 9 months after starting stavudine, lamivudine and nevirapine [serum enzymes normal, pH 7.15, lactate 5.3, glucosuria, phosphaturia], improving stopping therapy).
van Griensven J, Atté EF, Reid T. (2008). Symptomatic hyperlactatemia: lessons learned using a point-of-care device in a health care center- and nurse-based antiretroviral program in Rwanda. Clin Infect Dis. (Attempt at standardized approach for early recognition of symptoms and signs of hyperlactatemia with limited testing resources).
Soriano V, Puoti M, Garcia-Gascó P, Rockstroh JK, Benhamou Y, Barreiro P, McGovern B. (2008). Antiretroviral drugs and liver injury. AIDS. (Review of hepatotoxicity of antiretroviral drugs with recommendations on management, stopping therapy if symptoms arise, with overt jaundice [direct bilirubin], evidence of mitochondrial toxicity, ALT >10 times ULN, ALT at lower levels if newly marketed agent; important to rule out other causes, problematic agents include didanosine, stavudine and zidovudine; nevirapine and efavirenz, full dose ritonavir and tipranavir).
Kumarasamy N, Venkatesh KK, Cecelia AJ, Devaleenal B, Lai AR, Saghayam S, Balakrishnan P, Yepthomi T, Poongulali S, Flanigan TP, Solomon S, Mayer KH. (2008). Spectrum of adverse events after generic HAART in southern Indian HIV-infected patients. AIDS Patient Care STDS. (Among 3154 patients with HIV infection treated with antiretroviral agents over a 4 year period at a single center in Southern India, hepatitis occurred in 3.5% usually within the first 3 months; lactic acidosis was more common in women and was associated with stavudine use).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 7 were attributed to antiretroviral agents, 2 nevirapine, 1 efavirenz and 4 miscellaneous combinations).
Ingiliz P, Benhamou Y. (2009). Elevated liver enzymes in HIV monoinfected patients on HIV therapy: what are the implications?. J HIV Ther. (Review of the causes of serum enzyme elevations during antiretroviral therapy; nucleoside analogues can cause lactic acidosis but vary considerably in risk).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, 3 antiretroviral agents were among the top 40 cases, including zidovudine [8th, 106 cases], lamivudine [26th, 45 cases] and nevirapine [36th, 37 cases]).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 4 to antiretroviral agents, including 3 to combinations with stavudine and 1 to abacavir).
Moses M, Zachariah R, Tayler-Smith K, Misinde D, Foncha C, Manzi M, Bauerfeind A, et al. (2010). Outcomes and safety of concomitant nevirapine and rifampicin treatment under programme conditions in Malawi. Int J Tuberc Lung Dis. (Among 156 African patients with HIV infection and tuberculosis starting treatment with stavudine, lamivudine and nevirapine and given isoniazid, rifampin and pyrazinamide for tuberculosis, ALT elevations >5 times ULN developed in only one patient and none had clinically apparent liver injury).
van Griensven J, Zachariah R, Rasschaert F, Mugabo J, Atté EF, Reid T. (2010). Stavudine- and nevirapine-related drug toxicity while on generic fixed-dose antiretroviral treatment: incidence, timing and risk factors in a three-year cohort in Kigali, Rwanda. Trans R Soc Trop Med Hyg. (In a cohort study of 2190 adults receiving antiretroviral therapy, hepatotoxicity arose in 1.3% of patients taking nevirapine, but in none of those on stavudine).
Kovari H, Ledergerber B, Battegay M, Rauch A, Hirschel B, Foguena AK, Vernazza P, et al. (2010). Incidence and risk factors for chronic elevation of alanine aminotransferase levels in HIV-infected persons without hepatitis b or c virus co-infection. Clin Infect Dis. (Among 2365 HIV-infected patients followed longitudinally, 26% of those on stavudine had liver test abnormalities, which also correlated with zidovudine use, increased BMI, and elevated HIV RNA levels).
Fielder J, Rambiki K. (2010). Occurrence of stavudine-induced lactic acidosis in 3 members of an African family. J Int Assoc Physicians AIDS Care (Chic). (A 35 year old father, 29 year old mother and 5 year old child all developed high lactate levels and gastrointestinal symptoms 1-2 years after starting stavudine with nevirapine and lamivudine [ALT 89, 231 U/L and not given, lactate 4.4, 7.9 and 5.3 μmol/L, arterial pH not given], resolving slowly over 3-6 months).
Menezes CN, Maskew M, Sanne I, Crowther NJ, Raal FJ. (2011). A longitudinal study of stavudine-associated toxicities in a large cohort of South African HIV infected subjects. BMC Infect Dis. (Analysis of cohort of 8497 adults started on stavudine based antiretroviral therapy followed for median of 19 months found incidence of lactic acidosis to be 1.6 and symptomatic hyperlactataemia 3.6 per 100 person years, risk factors being higher BMI and female sex).
Hartleb M, Gutkowski K, Milkiewicz P. (2011). Nodular regenerative hyperplasia: evolving concepts on underdiagnosed cause of portal hypertension. World J Gastroenterol. (Review of etiology, course and management of nodular regenerative hyperplasia; mentions its association with azathioprine, mercaptopurine, thioguanine, oxaliplatin and antiretroviral agents).
Dlamini J, Ledwaba L, Mokwena N, Mokhathi T, Orsega S, Tsoku M, Kowo H, et al. (2011). Lactic acidosis and symptomatic hyperlactataemia in a randomized trial of first-line therapy in HIV-infected adults in South Africa. Antivir Ther. (Among 1771 patients with HIV infection treated with one of 4 antiviral regimens with didanosine or stavudine, 13 developed lactic acidosis [3.5/1000 patient-years]; lactic acidosis cases were more likely female, with higher BMI and exposure to stavudine).
Feeney ER, Chazallon C, O'Brien N, Meiffrédy V, Goodall RL, Aboulker JP, Cooper DA, et al., INITIO Trial International Co-ordinating Committee. (2011). Hyperlactataemia in HIV-infected subjects initiating antiretroviral therapy in a large randomized study (a substudy of the INITIO trial). HIV Med. (Among 911 patients with HIV infection started on antiretroviral therapy with didanosine and stavudine, 24 developed elevated lactate levels; abnormalities were more frequent in women than men and those with higher BMI; not predicted by or accompanied by peripheral lymphocyte mitochondrial DNA levels).
Schiano TD, Uriel A, Dieterich DT, Fiel MI. (2011). The development of hepatoportal sclerosis and portal hypertension due to didanosine use in HIV. Virchows Arch. (45 year old man with HIV infection developed nodular regenerative hyperplasia 5 years after starting a regimen of didanosine, stavudine and protease inhibitors that progressed despite switching to zidovudine, lamivudine, abacavir and tenofovir, with biopsy 5 years later showing hepatoportal sclerosis).
Cotte L, Bénet T, Billioud C, Miailhes P, Scoazec JY, Ferry T, Brochier C, et al. (2011). The role of nucleoside and nucleotide analogues in nodular regenerative hyperplasia in HIV-infected patients: a case control study. J Hepatol. (Case controlled study of 13 patients with HIV infection and nodular regenerative hyperplasia [NRH] and 78 HIV infected controls found that age, duration of didanosine and stavudine therapy were independently associated with NRH).
Blanco F, Barreiro P, Ryan P, Vispo E, Martín-Carbonero L, Tuma P, Labarga P, et al. (2011). Risk factors for advanced liver fibrosis in HIV-infected individuals: role of antiretroviral drugs and insulin resistance. J Viral Hepat. (Among 681 unselected patients with HIV infection undergoing ultrasound elastography, 215 had elevated values [>9.5 kPa] which were independently associated with HCV coinfection, ALT elevations, history of alcohol abuse, abnormal HOMA values and exposure to didanosine or stavudine).
Kalyesubula R, Kagimu M, Opio KC, Kiguba R, Semitala CF, Schlech WF, Katabira ET. (2011). Hepatotoxicity from first line antiretroviral therapy: an experience from a resource limited setting. Afr Health Sci. (Among 240 adults starting one of 3 antiretroviral regimens, 66 [27%] had new onset of ALT or AST elevations during first 3 months of therapy, but only 10 [4.2%] with ALT >2.5 times ULN, 5 with jaundice, no deaths).
Domingo P, Cabeza MC, Pruvost A, Torres F, Salazar J, del Mar Gutierrez M, Mateo MG, et al. (2011). Association of thymidylate synthase gene polymorphisms with stavudine triphosphate intracellular levels and lipodystrophy. Antimicrob Agents Chemother. (Analysis of polymorphisms in the thymidylate synthase [TS] gene in patients with and without lipodystrophy found an association of higher intracellular stavudine TP levels in white cells, “low expression” TS variants and lipodystrophy).
Castelnuovo B, Kiragga A, Kamya MR, Manabe Y. (2011). Stavudine toxicity in women is the main reason for treatment change in a 3-year prospective cohort of adult patients started on first-line antiretroviral treatment in Uganda. J Acquir Immune Defic Syndr. (Among 704 adults started on antiretroviral therapy with stavudine or zidovudine and followed for a median of 33 months, 91 had a drug treatment change because of toxicity, 87 [84%] were for stavudine).
Palmer M, Chersich M, Moultrie H, Kuhn L, Fairlie L, Meyers T. (2013). Frequency of stavudine substitution due to toxicity in children receiving antiretroviral treatment in Soweto, South Africa. AIDS. (Among 2222 children starting antiretroviral therapy for HIV infection between 2004 and 2008 followed for an average of 18 months, 96 developed stavudine toxicity including 87 cases of lipodystrophy and 3 of lactic acidosis).
Menezes CN, Duarte R, Dickens C, Dix-Peek T, Van Amsterdam D, John MA, Ive P, et al. (2013). The early effects of stavudine compared with tenofovir on adipocyte gene expression, mitochondrial DNA copy number and metabolic parameters in South African HIV-infected patients: a randomized trial. HIV Med. (Among 60 adults started on antiretroviral therapy, at 4 weeks adipocyte mitochondrial DNA decreased by 22-35% in stavudine treated vs 4% in tenofovir treated patients).
van Oosterhout JJ, Mallewa J, Kaunda S, Chagoma N, Njalale Y, Kampira E, Mukaka M, et al. (2012). Stavudine toxicity in adult longer-term ART patients in Blantyre, Malawi. PLoS One. (Monitoring of 253 adults enrolling in an antiretroviral program for HIV infection in Malawi found incident rates for any adverse event as 27 per 100 person-years, including peripheral neuropathy [20 per 100 person years], lipodystrophy [11], high lactate [2.1]).
Morén C, Noguera-Julian A, Garrabou G, Catalán M, Rovira N, Tobías E, Cardellach F, et al. (2012). Mitochondrial evolution in HIV-infected children receiving first- or second-generation nucleoside analogues. J Acquir Immune Defic Syndr. (Among 28 children with HIV infection, lactate levels rose and cytochrome c oxidase activity in white cells fell in those treated with first generation nucleoside analogues for up to 2 years [including stavudine: n=15], but not in those on second generation agents [n=13]).
Schouten JN, Van der Ende ME, Koëter T, Rossing HH, Komuta M, Verheij J, van der Valk M, et al. (2012). Risk factors and outcome of HIV-associated idiopathic noncirrhotic portal hypertension. Aliment Pharmacol Ther. (Comparison of 16 patients with HIV infection and NCPH vs 64 controls identified in the Netherlands, cases were younger [44 vs 52 years], had lower CD4 counts, higher ALT and Alk P, and more likely to have received didanosine [16] or stavudine [11] or both).
Phan V, Thai S, Choun K, Lynen L, van Griensven J. (2012). Incidence of treatment-limiting toxicity with stavudine-based antiretroviral therapy in Cambodia: a retrospective cohort study. PLoS One. (Retrospective analysis of cohort of 2581 adults initiating stavudine based regimens for HIV infection found rates of discontinuation of stavudine to be 11% for neuropathy, 37% lipodystrophy and 0.5% [n=14] for lactic acidosis; risk factors for lactic acidosis being female sex, higher BMI and concurrent therapy for tuberculosis).
Mateo MG, del Mar Gutierrez M, Vidal F, Domingo P. (2012). Drug safety evaluation profile of stavudine plus lamivudine for HIV-1/AIDS infection. Expert Opin Drug Saf. (Review of the safety of stavudine and lamivudine as an antiretroviral regimen in resource limited settings; while no longer recommended in the developed world, stavudine may have a role, “if there is no other chance” for antiretroviral therapy).
Dragovic G, Jevtovic D. (2012). The role of nucleoside reverse transcriptase inhibitors usage in the incidence of hyperlactatemia and lactic acidosis in HIV/AIDS patients. Biomed Pharmacother. (Among 396 patients with HIV infection started on antiretroviral therapy, hyperlactemia developed in 19 [none died] and lactic acidosis in 15 [4 died]; risk factors for lactic acidosis were exposure to didanosine [n=3], stavudine [n=4] or both [n=8]).
Arenas-Pinto A, Weller I, Ekong R, Grant A, Karstaedt A, Reiss P, Telisinghe L, Weber R, Bolhaar M, Bradman N, Ingram C. (2012). Common inherited mitochondrial DNA mutations and nucleoside reverse transcriptase inhibitor-induced severe hyperlactataemia in HIV-infected adults: an exploratory study. Antivir Ther. (Among 40 South African patients with HIV infection who developed hyperlactemia on stavudine based therapy, distribution of mitochondrial DNA haplotypes was the same as in controls).
Barlow-Mosha L, Eckard AR, McComsey GA, Musoke PM. (2013). Metabolic complications and treatment of perinatally HIV-infected children and adolescents. J Int AIDS Soc. (Review of metabolic complications [including lipodystrophy and lactic acidosis] of long term antiretroviral therapy in children and adolescents).
Vispo E, Cevik M, Rockstroh JK, Barreiro P, Nelson M, Scourfield A, Boesecke C, et al., European Network of Clinical Trials (NEAT). (2013). Genetic determinants of idiopathic noncirrhotic portal hypertension in HIV-infected patients. Clin Infect Dis. (Case control study of 22 HIV infected patients with noncirrhotic portal hypertension [NCPH] and 58 controls for single nucleotide polymorphisms in genes for enzymes involved in purine metabolism identified 2 single nucleotide polymorphisms in the 5-nucleotidase and 2 in the xanthine oxidase genes associated with presence of NCPH).
Verheij J, Schouten JN, Komuta M, Nevens F, Hansen BE, Janssen HL, Roskams T. (2013). Histological features in western patients with idiopathic non-cirrhotic portal hypertension. Histopathology. (Histological analysis of 70 patients with NCPH, 13 with HIV infection who were more likely to have NRH [93% vs 46%] and who had a similar risk for underlying thrombophilic condition [31% vs 40%]).
Wagner TA, Lin CH, Tobin NH, Côté HC, Sloan DD, Jerome KR, Frenkel LM. (2013). Quantification of mitochondrial toxicity in HIV-infected individuals by quantitative PCR compared to flow cytometry. Cytometry B Clin Cytom. (Ratios of concentrations of mitochondrial vs nuclear DNA and proteins in peripheral blood mononuclear cells were similar in patients with or without clinical evidence of mitochondrial injury due to antiretroviral therapy).
van Oosterhout JJ, Gardner K, Mallewa J, Kaunda S, Kampira E, Payne B, Heyderman RS, et al. (2013). Severe toxicity and polymerase-γ gene abnormalities in Malawian adults on stavudine-based antiretroviral therapy. Pharmacogenet Genomics. (Among 14 patients with severe stavudine toxicity [lactate syndromes, neuropathy, lipodystrophy], none had mutations in the POLG gene, suggesting that heterozygosity for these gene mutations is not a risk factor for mitochondrial toxicity of stavudine).
Chagoma N, Mallewa J, Kaunda S, Njalale Y, Kampira E, Mukaka M, Heyderman RS, et al. (2013). Longitudinal lactate levels from routine point-of-care monitoring in adult Malawian antiretroviral therapy patients: associations with stavudine toxicities. Trans R Soc Trop Med Hyg. (Among 253 patients with HIV infection on stavudine based antiretroviral therapy who were monitored for serum lactate levels, 210 [83%] had at least one elevation and 64 [26%] had sustained elevations).
Menezes CN, Crowther NJ, Duarte R, Van Amsterdam D, Evans D, Dickens C, Dix-Peek T, et al. (2014). A randomized clinical trial comparing metabolic parameters after 48 weeks of standard- and low-dose stavudine therapy and tenofovir disoproxil fumarate therapy in HIV-infected South African patients. HIV Med. (Among 60 patients with HIV infection treated with either [low or standard dose] stavudine vs tenofovir for 48 weeks, mitochondrial DNA copies decreased by 4% among tenofovir vs 29-32% among stavudine treated patients, and 3 cases of lactic acidosis occurred in stavudine vs none in the tenofovir treated subjects).
Sood A, Castrejón M, Saab S. (2014). Human immunodeficiency virus and nodular regenerative hyperplasia of liver: A systematic review. World J Hepatol. (A review of the literature on nodular regenerative hyperplasia in HIV infected patients).
Yajima K, Uehira T, Otera H, Koizumi Y, Watanabe D, Kodama Y, Kuzushita N, et al. (2014). A case of non-cirrhotic portal hypertension associated with anti-retroviral therapy in a Japanese patient with human immunodeficiency virus infection. J Infect Chemother. (35 year old Japanese woman with HIV infection presented with ascites and gastrointestinal bleeding 4 years after stopping a 5 year course of didanosine [bilirubin 0.2 mg/dL, ALT 82 U/L, AST 83 U/L, Alk P 268 U/L, platelets 207,000 /µL, TE=9.3 kPa, biopsy showing no cirrhosis], with improvement and resolution of ascites and abnormal liver tests after control of bleeding and avoidance of nucleoside analogs).
Parikh ND, Martel-Laferriere V, Kushner T, Childs K, Vachon ML, Dronamraju D, Taylor C, et al. (2014). Clinical factors that predict noncirrhotic portal hypertension in HIV-infected patients: a proposed diagnostic algorithm. J Infect Dis. (Comparison of 35 HIV infected persons with noncirrhotic portal hypertension to 68 controls identified multiple clinical differences; authors propose a diagnostic algorithm that includes exposure to didanosine, splenomegaly, low platelet count or serum enzyme elevations as suggestive of diagnosis and warranting further evaluation).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 5 of which [3%] were attributed to antiretroviral agents [nevirapine, zidovudine and lamivudine], but none to stavudine).
Brescini L, Orsetti E, Gesuita R, Piraccini F, Marchionni E, Staffolani S, Castelli P, et al. (2014). Evaluating liver fibrosis by transient elastometry in patients with HIV-HCV coinfection and monoinfection. Hepat Mon. (Among 354 adults undergoing transient elastography (TE), abnormal stiffness was found in 13% with HIV infection alone, 39% with HCV infection alone and 51% with both; treatment with stavudine and didanosine being associated with higher TE scores).
Turon F, Silva-Junior G, Hernandez-Gea V, Garcia-Pagan JC. (2015). Hipertensión portal idiopática no cirrótica. Gastroenterol Hepatol. (Review of noncirrhotic portal hypertension including epidemiology, pathogenesis, clinical presentation and management).
Arora A, Sarin SK. (2015). Multimodality imaging of obliterative portal venopathy: what every radiologist should know. Br J Radiol. (Review of the radiologic findings of noncirrhotic portal hypertension that accompanies obliterative portal venopathy; typical findings being increased spleen size and stiffness with normal or shrunken liver, portal vein enlargement and varices).
Ioannou GN, Bryson CL, Weiss NS, Boyko EJ. (2015). Associations between lipodystrophy or antiretroviral medications and cirrhosis in patients with HIV infection or HIV/HCV coinfection. Eur J Gastroenterol Hepatol. (In an analysis of the Veterans Administration Healthcare system Clinical Care Registry, long term use of didanosine but not other antiretroviral agents was found to be a risk factor for cirrhosis in patients with HIV monotherapy in contrast to patients with HIV-HCV coinfection, in whom all long term antiretroviral therapies were risk factors for cirrhosis).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 cases [1.3%] were attributed to antiretroviral agents, including one to zidovudine and one to didanosine but none to stavudine).
Kovari H, Sabin CA, Ledergerber B, Ryom L, Reiss P, Law M, Pradier C, et al. (2016). Antiretroviral drugs and risk of chronic alanine aminotransferase elevation in human immunodeficiency virus (HIV)-monoinfected persons: the data collection on adverse events of anti-HIV drugs study. Open Forum Infect Dis. (Among 21,495 persons observed for an average of 4-5 years in a prospective observation study of adverse events among HIV positive patients without HBV or HCV on antiretroviral therapy, 6368 [30%] developed chronically elevated liver tests [6 per 100 patient years] and risk factors included didanosine, stavudine and tenofovir therapy but not lamivudine, abacavir or most protease inhibitors).
Vilarinho S, Sari S, Yilmaz G, Stiegler AL, Boggon TJ, Jain D, Akyol G, et al. (2016). Recurrent recessive mutation in deoxyguanosine kinase causes idiopathic noncirrhotic portal hypertension. Hepatology. (Complete exome sequencing of DNA from 8 children with idiopathic noncirrhotic portal hypertension identified an extremely rare gene variant which was homozygous in all 8 children, the gene being deoxyguanosine kinase, an enzyme required for mitochondrial DNA replication that is also inhibited by didanosine, perhaps explaining its hepatotoxicity).
Ryom L, Lundgren JD, De Wit S, Kovari H, Reiss P, Law M, El-Sadr W, et al. (2016). D:A:D Study Group. Use of antiretroviral therapy and risk of end-stage liver disease and hepatocellular carcinoma in HIV-positive persons. AIDS. (Among 45,544 individuals followed for a median of 8.4 years in a prospective observation study of adverse events in patients with HIV infection on antiretroviral drugs, 209 developed end stage liver disease and 110 hepatocellular carcinoma, the combined rate being 1 per 1000 patient years; increase risk for these outcomes occurred in those with HCV and HBV infection but was also linked to long-term therapy with stavudine, didanosine, and tenofovir).
Ahmad AK, Atzori S, Taylor-Robinson SD, Maurice JB, Cooke GS, Garvey L. (2019). Spleen stiffness measurements using point shear wave elastography detects noncirrhotic portal hypertension in human immunodeficiency virus. Medicine (Baltimore). (Among 25 patients with HIV infection undergoing shearwave elastography, spleen stiffness was more reliable than liver stiffness in assessing noncirrhotic portal hypertension, being elevated in 6 of 11 cases of NCPH but in none of 14 controls).
Venter WDF, Kambugu A, Chersich MF, Becker S, Hill A, Arulappan N, Moorhouse M, et al. (2019). Efficacy and safety of tenofovir disoproxil fumarate versus low-dose stavudine over 96 weeks: a multicountry randomized, noninferiority trial. J Acquir Immune Defic Syndr. (Among 1072 patients with HIV infection treated with stavudine or tenofovir [both combined with lamivudine and efavirenz], response rates were similar while drug related adverse events were more frequent with stavudine [31% vs 25%], including lipodystrophy [5.6% vs 0.2%], lactic acidosis [0.8% vs none] and discontinuations for adverse events [6.7% vs 1.1%]).

## OTHER REFERENCE LINKS

1 Recent References on Stavudine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Stavudine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Stavudine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Stavudine)